# Sacituzumab Govitecan

## OVERVIEW

### Introduction

Sacituzumab govitecan is a humanized monoclonal antibody conjugate which is used in the therapy of refractory, locally advanced or metastatic breast and urothelial cancer. Sacituzumab govitecan has been linked to transient mild-to-moderate serum enzyme elevations during therapy but has not been implicated in cases of liver injury with jaundice.

### Background

Sacituzumab (sak” i tooz’ ue mab) govitecan (go vit’ e kan) is a humanized monoclonal antibody to the trophoblast-cell surface antigen (Trop-2), a glycoprotein that is highly expressed in various forms of cancer, including breast and urothelial cancer. The monoclonal antibody is conjugated by a linker segment to govitecan, a cytotoxic topoisomerase 1 inhibitor. When sacituzumab govitecan binds to Trop-2 on the surface of cancer cells, it is internalized, and the govitecan is released by the action of lysosomal enzymes which cleave the short linker molecule that joins the antibody and the cytotoxic molecule. The intracellular govitecan causes single-stranded DNA breaks that lead to apoptotic cell death of the dividing cancer cells. This monoclonal antibody conjugate has been shown to be effective in inducing remissions in adults with refractory, locally advanced or metastatic breast and urothelial cancers that express Trop-2. Sacituzumab govitecan was given accelerated approval for treatment of adults with refractory or relapsed advanced or metastatic forms of triple-negative breast cancer in the United States in 2020. Subsequently, indications have been extended to include refractory, locally advanced or metastatic urothelial cancer in 2021 and some forms of refractory, advanced or metastatic hormone receptor positive breast cancer in 2023. Sacituzumab govitecan is available as powder for reconstitution in single dose vials of 180 mg under the brand name Trodelvy. The typical recommended dose regimen is 10 mg/kg administered by intravenous infusion on days 1 and 8 of continuous 21-day cycles to be continued until disease progression or unacceptable toxicity. Premedication before each infusion for prevention of infusion reactions and nausea is recommended. Side effects are common and may include infusion reactions, neutropenia, anemia, nausea and vomiting, diarrhea, constipation, anorexia, abdominal pain, weakness, fatigue, headache, alopecia, fever, pruritus, and rash. Less common, but potentially serious side effects included severe hypersensitivity reactions, myelosuppression, febrile neutropenia, severe nausea and vomiting, and embryo-fetal toxicity. Sacituzumab govitecan should be administered only by physicians and health care providers with training and expertise in cancer chemotherapy and management of its potential adverse effects.

### Hepatotoxicity

In publications of the registration trials of sacituzumab govitecan, serum aminotransferase elevations arose in 11% to 35% of treated patients but were above 5 times the upper limit of normal (ULN) in only 1% to 2%, and no patient developed clinically apparent liver injury attributed to therapy. The conjugated govitecan is an active metabolite of irinotecan which is a well-known cause of hepatic steatosis and liver injury, but cases were rarely clinically apparent. Since its approval and more widespread use, there have been no published instances of clinically apparent liver injury attributed to sacituzumab govitecan in the literature, although reports of liver injury uncertain reliability and severity have been received by the FDA.

Likelihood score: E* (suspected but unproven cause of clinically significant liver injury).

### Mechanism of Injury

The cause of the serum enzyme elevations during sacituzumab govitecan therapy is not known, but it is likely due to direct toxicity of the govitecan conjugate rather than the monoclonal antibody. It is not known whether the serum enzyme elevations are accompanied by hepatic steatosis.

### Outcome and Management

The serum aminotransferase elevations that occur during sacituzumab govitecan therapy are generally transient, mild and asymptomatic and rarely require dose modification or delay in therapy. Elevations above 5 times the upper limit of normal, if detected, should lead to more careful monitoring and suspension of further infusions, at least until levels return to normal or near normal levels. Elevations above 20 times the ULN or any elevation accompanied by jaundice or symptoms should lead to prompt permanent discontinuation.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

Other Monoclonal Antibody Conjugates: Ado-Trastuzumab Emtansine, Benlantamab Mafodotin, Brentuximab Vedotin, Enfortumab Vedotin, Gemtuzumab Ozogamicin, Inotuzumab Ozogamicin, Polatuzumab Vedotin, Tisotumab Vedotin, Trastuzumab Deruxtecan

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sacituzumab Govitecan – Trodelvy®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Sacituzumab%20Govitecan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Sacituzumab Govitecan | 1491917-83-9 (https://pubchem.ncbi.nlm.nih.gov/compound/Sacituzumab-govitecan) | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 30 November 2023

Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/761115Orig1s000MultidisciplineR.pdf (FDA website with product labels and initial multidiscipline review of sacituzumab govitecan mentions that the most common side effects were diarrhea and neutropenia and that ALT elevations above 5 times ULN in 1.5% of patients in the safety population of 408 exposed patients; no discussion of serious hepatoxicity).
Bardia A, Mayer IA, Diamond JR, Moroose RL, Isakoff SJ, Starodub AN, Shah NC, et al. Efficacy and safety of anti-trop-2 antibody drug conjugate sacituzumab govitecan (IMMU-132) in heavily pretreated patients with metastatic triple-negative breast cancer. J Clin Oncol. 2017;35:2141-2148. (Among 69 adults with refractory or relapsed, metastatic triple-negative breast cancer treated with sacituzumab govitecan, the objective response rate was 30%, all responders having moderate to strong Trop-2 expression in cancer cells; side effects were not listed except for severe diarrhea [24%] and febrile neutropenia [7%]). 28291390
Bardia A, Mayer IA, Vahdat LT, Tolaney SM, Isakoff SJ, Diamond JR, O'Shaughnessy J, et al. Sacituzumab govitecan-hziy in refractory metastatic triple-negative breast cancer. N Engl J Med. 2019;380:741-751. (Among 108 adults with refractory metastatic triple negative breast cancer treated with sacituzumab govitecan, the objective response rate was 33% and overall survival 13 months, while the most common adverse events were nausea, diarrhea, fatigue, neutropenia, and anemia, and serious adverse events occurred in 32% leading to dose adjustments in 44%, discontinuations in 3%, and death in 4% of treated patients; ALT elevations occurred in 14% and were above 5 times ULN in 1% ). 30786188
Joubert N, Beck A, Dumontet C, Denevault-Sabourin C. Antibody-drug conjugates: the last decade. Pharmaceuticals (Basel). 2020;13:245. (Review of the development, structure, efficacy, adverse event rates and approval of vector-based chemotherapy using selective delivery by a monoclonal antibody and cancer cell injury by a conjugated cellular toxin [payload] including nine that are FDA approved and six others in pivotal trials). 32937862
Sacituzumab govitecan (Trodelvy) for metastatic triple-negative breast cancer. Med Lett Drugs Ther. 2021;63:e25-e27. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of sacituzumab govitecan shortly after its approval for use in breast cancer in the US mentioned the boxed warning in its product label for life-threatening neutropenia [9%] and severe diarrhea; no mention of ALT elevations or hepatotoxicity). 33757114
Rugo HS, Bardia A, Marmé F, Cortés J, Schmid P, Loirat D, Trédan O, et al. Overall survival with sacituzumab govitecan in hormone receptor-positive and human epidermal growth factor receptor 2-negative metastatic breast cancer (TROPiCS-02): a randomised, open-label, multicentre, phase 3 trial. Lancet. 2023;402(10411):1423-1433. (Among 543 patients with refractory locally advanced or metastatic triple negative breast cancer treated with sacituzumab govitecan vs standard chemotherapy, median overall survival was 24% vs 11 months while adverse events were consistent with previous studies and “manageable”). 37633306
In brief: A new breast cancer indication for sacituzumab govitecan (Trodelvy). Med Lett Drugs Ther. 2023;65:e43-e44. (Concise review of the mechanism of action, clinical efficacy, and safety of sacituzumab govitecan shortly after its expanded approval for treatment of breast cancer to endocrine-resistant, locally advanced or metastatic hormone receptor [HR]-positive, human epidermal growth factor receptor 2 [HER2]-negative breast cancer; no mention of ALT elevations or hepatotoxicity). 36877286
Tagawa ST, Balar AV, Petrylak DP, Kalebasty AR, Loriot Y, Fléchon A, Jain RK, et al. TROPHY-U-01: a phase II open-label study of sacituzumab govitecan in patients with metastatic urothelial carcinoma progressing after platinum-based chemotherapy and checkpoint inhibitors. J Clin Oncol. 2021;39:2474-2485. (Among 113 patients with refractory, locally advanced or metastatic urothelial cancer treated with sacituzumab govitecan, the objective response rate was 27% and the adverse event rate was 98%, and common side effects included diarrhea, nausea, fatigue, alopecia, neutropenia, decreased appetite, anemia and leukopenia, which led to dose reductions in 39%, interruptions in 45%, and discontinuations in 6%; no mention of ALT elevations or hepatotoxicity). 33929895
Sun C, Yang X, Tang L, Chen J. A pharmacovigilance study on drug-induced liver injury associated with antibody-drug conjugates (ADCs) based on the Food and Drug Administration Adverse Event Reporting System. Expert Opin Drug Saf. 2023 Oct 29:1-12. Epub ahead of print. (Analysis of the FDA reporting system [FAERS] for cases of drug induced liver injury submitted between 2004 and 2022, found 17,784 reports, 504 [3%] attributed to antibody-drug conjugates, 202 from the US, the implicated agents being gemtuzumab ozogamicin [n=98], brentuximab vedotin [n=37], trastuzumab emtansine [n=25], enfortumab vedotin [n=16], inotuzumab ozogamicin [n=15], transtuzumab deruxtecan [n=8], and polatuzumab vedotin [3]; while there were no reports of liver injury attributed to sacituzumab govitecan from the US, there were 10 from other countries including France). 37898875

## OTHER REFERENCE LINKS

Recent References on Sacituzumab Govitecan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Sacituzumab+AND+Govitecan+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Sacituzumab Govitecan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Sacituzumab%20Govitecan)